# Lorlatinib

## OVERVIEW

### Introduction

Lorlatinib is a selective tyrosine kinase receptor inhibitor used in the therapy of selected cases of advanced non-small cell lung cancer. Lorlatinib is associated with transient elevations in serum aminotransferase levels during treatment but has not been linked to instances of clinically apparent acute liver injury that have been described with other similar kinase inhibitors.

### Background

Lorlatinib (lor la' ti nib) is an orally available, small molecule inhibitor of the tyrosine kinase receptor of mutated anaplastic lymphoma kinase (ALK), which is the result of a chromosomal translocation found in about 5% of lung cancers. Patients with non-small cell lung cancer with the ALK mutation often respond to ALK inhibitor therapy with shrinkage of the tumor and apparent improvement in survival. However, resistance develops frequently as a result of further mutations in the cancer cells. Lorlatinib is a third generation ALK inhibitor that has activity against many of the known ALK resistance mutants. Lorlatinib received accelerated approval for use in the United States in 2018 for the treatment of refractory, advanced non-small cell lung cancer with the ALK translocation (a test for this genetic rearrangement was also approved). Lorlatinib is available in tablets of 25 and 100 mg under the brand name Lorbrena. The recommended dose is 100 mg by mouth once daily, with dose modification based upon tolerance. Side effects are common and include diarrhea, nausea, vomiting, anorexia, fatigue, diarrhea, visual disturbances, peripheral neuropathy, cognitive effects, dyspnea, weight gain, hyperlipidemia and edema. Uncommon, but potentially serious side effects include interstitial lung disease, atrial-ventricular block, QTc interval prolongation, cardiac arrhythmias and fetal-embryonal toxicity.

### Hepatotoxicity

In large early clinical trials, elevations in serum aminotransferase levels occurred in up to 28% of patients treated with standard doses of lorlatinib but were above 5 times ULN in only 2% of patients and rarely led to early discontinuation of therapy. The abnormalities were typically transient, asymptomatic and not associated with jaundice. In prelicensure clinical trials there were no instances of clinically apparent liver injury. In contrast, most other ALK inhibitors have been linked to instances of acute liver injury which can be severe and even fatal. The liver injury typically arises within 4 to 12 weeks of starting therapy and presents with marked elevations in serum aminotransferase levels followed by jaundice and progressive hepatic dysfunction. While lorlatinib has not been associated with instances of severe liver injury, it has had limited clinical use.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which lorlatinib might cause liver injury is unknown. Lorlatinib is metabolized in the liver largely via CYP 3A4, and liver injury may be due to accumulation of a toxic or immunogenic intermediate. Lorlatinib is susceptible to drug-drug interactions, and drugs that are strong inhibitors or inducers of CYP 3A should be avoided during its use.

### Outcome and Management

Routine monitoring of liver tests is recommended for patients starting lorlatinib and at intervals thereafter. Serum aminotransferase elevations above 5 times the upper limit of normal should lead to dose interruption. If changes persist, are severe, or reoccur on restarting, lorlatinib should be discontinued. Persons who develop liver injury using therapy with a specific ALK inhibitor can often be treated with other ALK inhibitors without recurrence of liver injury, but should be monitored carefully during treatment after hepatotoxicity from a related agent.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lorlatinib – Lorbrena®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Lorlatinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Lorlatinib | 1454846-35-5 | C21-H19-F-N6-O2 | Lorlatinib chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 15 April 2019

Abbreviations used: NSCLC, non-small cell lung cancer; ALK, anaplastic lymphoma kinase.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors).
DeLeve LD. Kinase inhibitors. Gefitinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents; crizotinib is listed as causing moderate-to-severe aminotransferase elevations in 4-7% of patients and as having caused fatal hepatotoxicity in some instances, but there is no mention of lorlatinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy).
Shaw AT, Engelman JA. ALK in lung cancer: past, present, and future. J Clin Oncol 2013; 31: 1105-11. (Review of the history of discovery of ALK mutations and development of crizotinib as therapy of NSCLC patients with this mutation; no discussion of lorlatinib or of hepatotoxicity or ALT elevations). 23401436
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 cases [6%] were attributed to antineoplastic agents, including 9 due to kinase inhibitors such as imatinib and lapatinib, but none were attributed to any of the small molecule ALK inhibitors). 25754159
Shaw AT, Friboulet L, Leshchiner I, Gainor JF, Bergqvist S, Brooun A, Burke BJ, et al. Resensitization to crizotinib by the lorlatinib ALK resistance mutation L1198F. N Engl J Med 2016; 374: 54-61. (52 year old woman with metastatic, ALK-mutation positive NSCLC was treated successfully with crizotinib but then developed resistant tumor that did not respond to ceritinib, but did to lorlatinib, only to later develop a lorlatinib resistant mutation that was predicted to be sensitive to crizotinib and responded dramatically to its reintroduction, both response and resistance being predicted by the sequential ALK mutations). 26698910
Shaw AT, Felip E, Bauer TM, Besse B, Navarro A, Postel-Vinay S, Gainor JF, et al. Lorlatinib in non-small-cell lung cancer with ALK or ROS1 rearrangement: an international, multicentre, open-label, single-arm first-in-man phase 1 trial. Lancet Oncol 2017; 18: 1590-9. (Among 54 patients with NSCLC treated with lorlatinib in different dose regimens, the objective response rate was 42-50% and adverse events included hypercholesterolemia [72%], edema [39%], peripheral neuropathy [39%], cognitive effects [24%] and AST elevations [13%]). 29074098
Betton M, Gounant V, Sannier A, Hanouna G, Goujon JM, Brosseau S, Zalcman G, et al. Minimal change disease induced by lorlatinib. J Thorac Oncol 2018; 13: e154-e156. (64 year old woman with NSCLC treated with lorlatinib developed leg edema and proteinuria one month after starting, renal biopsy showing minimal change glomerulonephritis, which resolved on stopping and recurred on restarting). 30049381
Chabrol A, Mayenga M, Hamid AM, Friard S, Salvator H, Doubre H, Fraboulet S, et al. Lorlatinib - induced pulmonary arterial hypertension. Lung Cancer 2018; 120: 60-1. (Two women, ages 55 and 64 years, developed dyspnea 1 and 2 months after starting lorlatinib for NSCLC and right heart catherization showed pulmonary arterial hypertension and decreased cardiac index, both improving upon stopping the ALK inhibitor therapy). 29748016
Solomon BJ, Besse B, Bauer TM, Felip E, Soo RA, Camidge DR, Chiari R, et al. Lorlatinib in patients with ALK-positive non-small-cell lung cancer: results from a global phase 2 study. Lancet Oncol 2018; 19: 1654-67. (Among 276 patients with NSCLC and ALK or ROS1 mutations, objective response rates varied from 32% to 67% and adverse events were frequent including hypercholesterolemia [81%], edema [43%], peripheral neuropathy [30%], cognitive effects [18%] and ALT elevations [9%], which were above 5 times ULN in only 1% and were not associated with jaundice or symptoms of liver injury). 30413378
Waqar SN, Morgensztern D. Lorlatinib: a new-generation drug for ALK-positive NSCLC. Lancet Oncol 2018; 19: 1555-7. (Commentary on Solomon [2018] mentions that lorlatinib has shown promise in treatment-naïve as well as experienced patients with NSCLC and ALK mutations). 30413381
Ryser CO, Diebold J, Gautschi O. Treatment of anaplastic lymphoma kinase-positive non-small cell lung cancer: update and perspectives. Curr Opin Oncol 2019; 31: 8-12. (Review of the management of NSCLC with ALK mutations using first [crizotinib], second [alectinib, ceritinib, brigatinib] and third generation [lorlatinib] ALK inhibitors; mentions hepatotoxicity of crizotinib and ceritinib). 30394941
Syed YY. Lorlatinib: first global approval. Drugs 2019; 79: 93-8. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy and safety of lorlatinib shortly after its approval in the US; mentions that 10% of patients had AST elevations during therapy but none required discontinuation or led to serious hepatic adverse events). 30604291

## OTHER REFERENCE LINKS

1. Recent References on Lorlatinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Lorlatinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Lorlatinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lorlatinib)